# Ursodiol (Ursodeoxycholic Acid)

## OVERVIEW

### Introduction

Ursodeoxycholic acid or ursodiol is a naturally occurring bile acid that is used dissolve cholesterol gall stones and to treat cholestatic forms of liver diseases including primary biliary cirrhosis. Ursodiol has been linked to rare instances of transient and mild serum aminotransferase elevations during therapy and to rare instances of jaundice and worsening of liver disease in patients with preexisting cirrhosis.

### Background

Ursodiol (ur" soe dye' ol) is a naturally occurring bile acid that is a minor fraction of the bile acid pool in humans, but a major fraction in bears and other hibernating animals. Ursodeoxycholic acid is more water soluble (hydrophilic) than cholic or chenodeoxycholic acid and is less inherently toxic to cells. When given orally, ursodeoxycholic acid becomes a major component of the bile acid pool, the proportion rising from <2% to as much as 65%. By replacing the hydrophobic or more toxic bile acids with ursodiol, the toxic effects of cholestasis are ameliorated. Unlike other primary bile acids, ursodiol has little agonist activity with FXR, the bile acid sensing nuclear receptor. As a consequence, ursodiol has little effect on cholesterol and lipid synthesis and is effective in reducing the cholesterol saturation of bile and in dissolving cholesterol gallstones. In addition, ursodiol has been shown to decrease serum enzyme elevations in a large number of cholestatic liver diseases including primary biliary cirrhosis, the cholestasis of pregnancy, and parenteral nutrition associated liver disease. In some situations, this improvement in liver enzyme levels has been accompanied by improvements in symptoms, liver histology and long term adverse outcomes of these diseases (cirrhosis, end stage liver disease). Ursodiol was approved for dissolution of gallstones in 1987 and as a therapy of primary biliary cirrhosis in 1996. It is also used off label in other cholestatic liver conditions including sclerosing cholangitis, graft-vs-host disease, cholestasis of pregnancy and the liver disease of cystic fibrosis. Ursodiol is available in tablets and capsules of 250 and 300 mg generically and under brand names such as Actigall and Urso. The typical initial dose for dissolution of gall stones is 8 to 10 mg/kg daily and for primary biliary cirrhosis is 13 to 15 mg daily in three divided doses with meals. Ursodiol is generally well tolerated; uncommon side effects can include fatigue, nausea, headache and weight gain. Less common, but potentially severe adverse reactions include hypersensitivity reactions and depression.

### Hepatotoxicity

n multiple clinical trials in a variety of conditions, ursodiol has not been found to cause increases in serum enzyme elevations, worsening of underlying liver disease or clinically apparent liver injury. Nevertheless, there have been rare reports of clinical decompensation in patients with advanced liver disease and cirrhosis started on ursodiol, but the reason for such reactions is not known. In at least one instance, there was recurrence of jaundice on restarting ursodiol. Thus, ursodiol has beneficial effects on several forms of liver disease and has not been convincingly linked to cases of clinically apparent acute liver injury in patients without cirrhosis. There is some concern that ursodiol may be harmful in patients with advanced liver disease (Childs class B and C) and such patients probably should not receive ursodiol.

Likelihood score: D (possible rare cause of acute decompensation of preexisting liver disease).

### Mechanism of Liver Injury

The mechanism by which ursodiol might cause liver injury is unclear as it is a natural occurring bile acid that is concentrated in the liver and usually replaces and suppresses the synthesis of more hydrophobic and potentially toxic bile acids. The rare instancers of worsening of liver disease during ursodiol therpay may be caused by the choleresis (increase in bile flow) that it stimulates rather to any intrinsic or idiosyncratic reaction to the drug itself.

### Outcome and Management

Patients with cirrhosis who are started on ursodiol should be monitored regularly for the first few months, and treatment discontinued if there is evidence of worsening of liver tests or of hepatic decompensation. There does not appear to be cross sensitivity to liver injury or adverse events between ursodiol and other bile acid therapies.

Other bile acids used in digestive diseases include chenodeoxycholic acid (chenodiol), cholic acid and obeticholic acid.

Drug Class: Gastrointestinal Agents, Bile Acids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ursodiol – Generic, Actigall®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ursodiol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ursodiol | 128-13-2 | C24-H40-O4 | Bile Acids Chemical Structure
Cholic Acid | 81-25-4 | C24-H40-O5 | Ursodiol Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 September 2017

Abbreviations used: FXR, farnesoid X receptor; NAFLD, nonalcoholic fatty liver disease; NASH, nonalcoholic steatohepatitis; OCA, obeticholic acid; PBC, primary biliary cirrhosis (cholangitis).

Zimmerman HJ. Bile acid derivatives. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 721. (Review of hepatotoxicity published in 1999; mentions that ursodiol is an isomer of chenodiol and poses “little demonstrable risk of hepatic injury” in humans, although it causes liver injury in rabbits and rhesus monkeys).
Sharkey KA, Wallace JL. Treatment of disorders of bowel motility and water flux: anti-emetics; agents used in biliary and pancreatic disease. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1323-50. (Textbook of pharmacology and therapeutics).
Schoenfield LJ, Lachin JM. Chenodiol (chenodeoxycholic acid) for dissolution of gallstones: the National Cooperative Gallstone Study. A controlled trial of efficacy and safety. Ann Intern Med 1981; 95; 257-82. (Among 916 patients with radiolucent gallstones treated with chenodiol [350 or 750 mg daily] vs placebo for 2 years, gallstone dissolution occurred in 5% and 13.5% vs 0% and ALT elevations in 13-19% vs 13%, which were above 3 times ULN in 5-8% vs 4% while biopsies showed nonspecific changes only; ALT elevations resolved even without stopping in most and among 17 who stopped therapy, 6 had recurrence on restarting; no patient developed clinically apparent liver injury). 7023307
Miyai K, Javitt NB, Gochman N, Jones HM, Baker D. Hepatotoxicity of bile acids in rabbits: ursodeoxycholic acid is less toxic than chenodeoxycholic acid. Lab Invest 1982; 46: 428-37. (Feeding rabbits chenodeoxycholic and lithocholic acid led to increases in ALT levels, histologic changes in the liver and significant mortality compared to no treatment or use of ursodiol). 7200166
Roda E, Bazzoli F, Labate AM, Mazzella G, Roda A, Sama C, Festi D, et al. Ursodeoxycholic acid vs. chenodeoxycholic acid as cholesterol gallstone-dissolving agents: a comparative randomized study. Hepatology 1982; 2: 804-10. (Among 223 patients with gallstones treated with ursodiol or chenodiol at 2 doses for 12 months, gallstone dissolution was similar at the higher doses but greater for ursodiol at the lower doses; ALT elevations occurred only in chenodiol groups [14%], but there were no concurrent elevations in Alk P or bilirubin). 7141392
Fromm H, Roat JW, Gonzalez V, Sarva RP, Farivar S. Comparative efficacy and side effects of ursodeoxycholic and chenodeoxycholic acids in dissolving gallstones. A double-blind controlled study. Gastroenterology 1983; 85: 1257-64. (Among 60 patients with radiolucent gallstones treated with chenodiol [375 or 750 mg] or ursodiol [400 or 800 mg] or placebo daily, complete dissolution occurred in 7% on chenodiol versus 30% on ursodiol, but none on placebo, while ALT elevations above 3 times ULN occurred in 2 of 26 on chenodiol but none of 24 on ursodiol). 6354826
Erlinger S, Le Go A, Husson JM, Fevery J. Franco-Belgian cooperative study of ursodeoxycholic acid in the medical dissolution of gallstones: a double-blind, randomized, dose-response study, and comparison with chenodeoxycholic acid. Hepatology 1984; 4: 308-14. (Among 197 patients with radiolucent gallstones treated with ursodiol or chenodiol, stone dissolution rates were similar, but diarrhea was less with ursodiol [5% vs 23%] and ALT elevations were transient and mild [less than twice normal] in all except one patient [3%] on chenodiol). 6706305
Fisher MM, Roberts EA, Rosen IE, Shapero TF, Sutherland LR, Davies RS, Bacchus R, Lee SV. The Sunnybrook Gallstone Study: a double-blind controlled trial of chenodeoxycholic acid for gallstone dissolution. Hepatology 1985; 5: 102-7. (Among 160 patients with radiolucent gallstones treated with chenodiol [375 or 750 mg daily] or placebo for 2 years, stone dissolution occurred in 11-13% vs 0% and no patient developed clinically apparent liver injury). 3881327
Nakashima T, Sano A, Seto Y, Nakajima T, Okuno T, Takino T. A case of hyperbilirubinemia during treatment with chenodeoxycholic acid. Jpn J Med 1987; 26: 404-8. (A 27 year old woman with acute, symptomatic cholelithiasis developed jaundice within 6 weeks of starting chenodiol [peak values 12.8 mg/dL, ALT normal, Alk P ~3 times ULN], resolving upon stopping, but later requiring cholecystectomy). 3694926
Vogel W, Kathrein H, Judmaier G, Braunsteiner H. Deterioration of primary biliary cirrhosis during treatment with ursodeoxycholic acid. Lancet 1988; 1 (8595): 1163. (64 year old man with PBC and early cirrhosis developed jaundice and ascites 2 months after starting ursodiol [bilirubin "tripled", ALT and Alk P levels "almost doubled"], with resolution on stopping, but recurrence of jaundice [bilirubin 8 mg/dL] and decompensation within days of restarting). 2896978
Poupon R, Poupon RE. Deterioration in primary biliary cirrhosis in patient on ursodeoxycholic acid. Lancet 1988; 2 (8603): 166-7. Reply by Authors. (Letter in response to Vogel et al [1988] suggesting that the hepatic decompensation was due to portal vein thrombosis or arterio-portal fistula from a liver biopsy rather than ursodiol; reply by the authors stating that the patient had not had a liver biopsy for 17 years and had no evidence of thrombosis or fistula on imaging). 2899219
Fisher RL, Hofmann AF, Converse JL, Rossi SS, Lan SP. The lack of relationship between hepatotoxicity and lithocholic-acid sulfation in biliary bile acids during chenodiol therapy in the National Cooperative Gallstone Study. Hepatology 1991; 14: 454-63. (Testing of bile samples from 31 patients with gallstones treated with chenodiol with and without liver test or liver biopsy abnormalities showed no differences in lithocholate levels during treatment with or without liver test abnormalities). 1874490
Poupon RE, Balkau B, Eschwège E, Poupon R. A multicenter, controlled trial of ursodiol for the treatment of primary biliary cirrhosis. UDCA-PBC Study Group. N Engl J Med 1991; 324: 1548-54. (Among 146 patients with PBC treated with ursodiol [13-15 mg daily] or placebo for 2 years, ALT, Alk P and bilirubin levels and liver histology [except for fibrosis] improved with ursodiol but not placebo; one patient on ursodiol required discontinuation because of worsening of pruritus; no mention of hepatotoxicity or other toxicities). 1674105
Beuers U, Spengler U, Kruis W, Aydemir U, Wiebecke B, Heldwein W, Weinzierl M, et al. Ursodeoxycholic acid for treatment of primary sclerosing cholangitis: a placebo-controlled trial. Hepatology 1992; 16: 707-14. (Among 14 patients with sclerosing cholangitis treated with ursodiol [13-15 mg/kg daily] or placebo for 1 year, Alk P, ALT and bilirubin improved with ursodiol and only one patient stopped ursodiol early because of side effects [diarrhea]). 1505913
Palma J, Reyes H, Ribalta J, Iglesias J, Gonzalez MC, Hernandez I, Alvarez C, et al. Effects of ursodeoxycholic acid in patients with intrahepatic cholestasis of pregnancy. Hepatology 1992; 15: 1043-7. (Among 8 patients with intrahepatic cholestasis of pregnancy treated with ursodiol [1 gm daily], all had marked improvements in Alk P, ALT and bilirubin levels and pruritus scores, all relapsing upon stopping therapy and responding again on restarting; no evidence of hepatotoxicity or significant toxicity). 1592342
Dubner H, Fromm H. Ursodeoxycholic acid treatment of intrahepatic cholestasis of pregnancy: observations on efficacy and safety. Gastroenterology 1993; 104: 660-1. (Commentary on Palma [1992] discussing the natural history of intrahepatic cholestasis of pregnancy and the need to better demonstrate the safety of ursodiol in pregnancy). 8425713
Daugherty CC, Setchell KD, Heubi JE, Balistreri WF. Resolution of liver biopsy alterations in three siblings with bile acid treatment of an inborn error of bile acid metabolism(delta 4-3-oxosteroid 5 beta-reductase deficiency). Hepatology 1993; 18: 1096-101. (Among 3 siblings with a bile acid synthetic defect and severe liver disease, treatment with cholic acid and ursodiol was followed by resolution of jaundice and improvements in ALT, Alk P and liver histology). 8225213
Heathcote EJ, Cauch-Dudek K, Walker V, Bailey RJ, Blendis LM, Ghent CN, Michieletti P, et al. The Canadian Multicenter Double-blind Randomized Controlled Trial of ursodeoxycholic acid in primary biliary cirrhosis. Hepatology 1994; 19: 1149-56. (Among 222 patients with PBC treated with ursodiol [14 mg/kg daily] or placebo for 24 months, ALT, Alk P and bilirubin levels and some features of histology [not fibrosis] improved with ursodiol therapy, but symptoms did not change and there were no differences in rates of death or liver transplantation; no mention of hepatotoxicity). 8175136
Lindor KD, Dickson ER, Baldus WP, Jorgensen RA, Ludwig J, Murtaugh PA, Harrison JM, et al. Ursodeoxycholic acid in the treatment of primary biliary cirrhosis. Gastroenterology 1994; 106: 1284-90. (Among 180 patients with PBC treated with ursodiol [13-15 mg/kg daily] or placebo for up to 4 years, there were improvements in Alk P, ALT, AST and bilirubin with ursodiol, but no significant change in liver histology or symptoms and a nonsignificant decrease in liver transplantation and mortality; no mention of ALT elevations or hepatotoxicity). 8174890
Combes B, Carithers RL Jr, Maddrey WC, Lin D, McDonald MF, Wheeler DE, Eigenbrodt EH, et al. A randomized, double-blind, placebo-controlled trial of ursodeoxycholic acid in primary biliary cirrhosis. Hepatology 1995; 22: 759-66. (Among 151 patients with PBC treated with ursodiol [10-12 mg/kg] or placebo for 2 years, decreases in bilirubin, ALT and Alk P as well as histological features improved mostly in patients with earlier stage disease, but there was no overall effect on rates of mortality or liver transplantation). 7657280
Bashir RM, Lewis JH. Hepatotoxicity of drugs used in the treatment of gastrointestinal disorders. Gastroenterol Clin North Am 1995; 24: 937-67. (Review of hepatotoxicity of drugs for gastrointestinal disease mentions that ALT elevations occur in up to 30% of patients treated with chenodiol and are above 3-4 times ULN in 2-3%, and that there have been at least 4 cases of clinically apparent liver injury reported to the sponsor whereas no such reports have been linked to ursodiol; no specific details of cases given). 8749906
Colombo C, Battezzati PM, Podda M, Bettinardi N, Giunta A. Ursodeoxycholic acid for liver disease associated with cystic fibrosis: a double-blind multicenter trial. The Italian Group for the Study of Ursodeoxycholic Acid in Cystic Fibrosis. Hepatology 1996; 23: 1484-90. (Among 55 patients with cystic fibrosis with liver disease treated with ursodiol [15 mg/kg daily], taurine, both or placebo, GGT, ALT and AST levels improved more in ursodiol treated patients and “no severe side effects were reported”, although one ursodiol treated patient developed jaundice and decompensation after 7 months and was withdrawn and underwent liver transplantation). 8675168
Hempfling W, Dilger K, Beuers U. Systematic review: ursodeoxycholic acid--adverse effects and drug interactions. Aliment Pharmacol Ther 2003; 18: 963-72. (Systematic review of side effects of ursodiol mentions that no severe adverse events or liver toxicities were reported in controlled clinical trials for gallstones or chronic cholestatic liver diseases, but instances of clinical decompensation were reported in patients with preexisting cirrhosis, suggesting that it should be used with caution in patients with advanced disease). 14616161
Combes B, Emerson SS, Flye NL, Munoz SJ, Luketic VA, Mayo MJ, McCashland TM, et al. Methotrexate (MTX) plus ursodeoxycholic acid (UDCA) in the treatment of primary biliary cirrhosis. Hepatology 2005; 42: 1184-93. (Among 265 patients with PBC treated with ursodiol with or without methotrexate for a median of 7.6 years, transplant-free survival was excellent and not affected by methotrexate therapy; no mention of unexplained ALT elevations or hepatotoxicity). 16250039
Beuers U. Drug insight: Mechanisms and sites of action of ursodeoxycholic acid in cholestasis. Nat Clin Pract Gastroenterol Hepatol 2006; 3: 318-28. (Review of the mechanism of action of ursodiol in cholestatic liver diseases). 16741551
Paumgartner G. Medical treatment of cholestatic liver diseases: From pathobiology to pharmacological targets. World J Gastroenterol 2006; 12: 4445-51. (Review of the pathogenesis of gallstone formation and medical therapies for gallstone dissolution). 16874853
Chiang JY. Bile acids: regulation of synthesis. J Lipid Res 2009; 50: 1955-66. (Review of the pathways of cholic and chenodeoxycholic acid synthesis and their regulation via FXR, FGF19, FGFR4 and CYP7A1). 19346330
Gonzales E, Gerhardt MF, Fabre M, Setchell KD, Davit-Spraul A, Vincent I, Heubi JE, et al. Oral cholic acid for hereditary defects of primary bile acid synthesis: a safe and effective long-term therapy. Gastroenterology 2009; 137: 1310-1320. (Among 15 patients with bile acid synthesis defects treated with oral bile acids [ursodiol and cholic acid initially and eventually cholic acid alone for all except one patient: 3-9 mg/kg daily] for 5-15 years, all had lasting clinical improvements shown by repeat liver biopsies in 14; overdose of cholic acid was marked by diarrhea, pruritus and increases in GGT and ALT that responded to dose modification). 19622360
Braga MF, Grace MG, Lenis J, Kennedy FP, Teplinsky AL, Roederer G, Palumbo PJ, et al. Efficacy and safety of ursodeoxycholic acid in primary, type IIa or IIb hypercholesterolemia: a multicenter, randomized, double-blind clinical trial. Atherosclerosis 2009; 203: 479-82. (Among 125 patients with hypercholesterolemia treated with ursodiol [13-15 mg/kg daily] or placebo for 24 weeks, changes in total, LDL and HDL cholesterol levels were similar in the two groups, while digestive disease complaints and withdrawals for adverse events were more common with ursodiol; no mention of ALT elevations or hepatotoxicity). 18801487
Lindor KD, Kowdley KV, Luketic VA, Harrison ME, McCashland T, Befeler AS, Harnois D, et al. High-dose ursodeoxycholic acid for the treatment of primary sclerosing cholangitis. Hepatology 2009; 50: 808-14. (Among 150 patients with primary sclerosing cholangitis treated with ursodiol [high doses: 28-30 mg/kg daily] or placebo for up to 5 years, improvements in ALT, Alk P and bilirubin were more common with ursodiol, but so were serious adverse events and clinical outcomes [death, liver transplantation and complications of cirrhosis]). 19585548
Imam MH, Sinakos E, Gossard AA, Kowdley KV, Luketic VA, Edwyn Harrison M, McCashland T, et al. High-dose ursodeoxycholic acid increases risk of adverse outcomes in patients with early stage primary sclerosing cholangitis. Aliment Pharmacol Ther 2011; 34: 1185-92. (Secondary analysis of trial of high dose ursodiol vs placebo in primary sclerosing cholangitis [Lindor 2009] found that the excess in mortality and complications of cirrhosis occurred in patients with earlier stage disease [endpoints occurring in 15.9% vs 4.5% with early stage disease]). 21957881
Ratziu V, de Ledinghen V, Oberti F, Mathurin P, Wartelle-Bladou C, Renou C, Sogni P, et al.; FRESGUN. A randomized controlled trial of high-dose ursodesoxycholic acid for nonalcoholic steatohepatitis. J Hepatol 2011; 54: 1011-9. (Among 126 patients with nonalcoholic steatohepatitis treated with ursodiol vs placebo for 12 months, serum ALT and GGT improved more with ursodiol and no patient in either group developed cirrhosis or died of liver disease; no mention of marked ALT elevations or hepatotoxicity). 21145828
Eaton JE, Silveira MG, Pardi DS, Sinakos E, Kowdley KV, Luketic VA, Harrison ME, et al. High-dose ursodeoxycholic acid is associated with the development of colorectal neoplasia in patients with ulcerative colitis and primary sclerosing cholangitis. Am J Gastroenterol 2011; 106: 1638-45. (Among 56 patients with sclerosing cholangitis and ulcerative colitis treated with high dose ursodiol or placebo for up to 5 years [Lindor 2009], those receiving ursodiol had a higher rate of colorectal cancer, the difference arising after 2.5 years of therapy). 21556038
Song P, Zhang Y, Klaassen CD. Dose-response of five bile acids on serum and liver bile acid concentrations and hepatotoxicty in mice. Toxicol Sci 2011; 123: 359-67. (Feeding of various concentrations of 5 different bile acids to mice demonstrated clear toxicity with lithocholic, cholic, deoxycholic and chenodeoxycholic acid, but little or no toxicity with ursodeoxycholic acid). 21747115
Joutsiniemi T, Timonen S, Leino R, Palo P, Ekblad U. Ursodeoxycholic acid in the treatment of intrahepatic cholestasis of pregnancy: a randomized controlled trial. Arch Gynecol Obstet 2014; 289: 541-7. (Among 20 pregnant women with intrahepatic cholestasis of pregnancy treated with ursodiol [450 mg daily] or placebo for 14 days, itching scores and serum levels of ALT and bilirubin improved more with ursodiol than placebo treatment). 23978872
Xue Q, Peng T, Wang J. [Ursodeoxycholic acid-induced hepatic disease: a case report]. Zhonghua Gan Zang Bing Za Zhi 2015; 23: 714-5. Chinese. (49 year old woman with suspected autoimmune hepatitis developed jaundice within a few days of starting ursodiol [bilirubin 9.1 mg/dL, ALT 724 U/L, Alk P 255 U/L] which improved on stopping and recurred upon restarting ursodiol at a lower dose). 26524371
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to ursodiol or other bile acid therapies). 25754159
Parízek A, Simják P, Cerný A, Sestinová A, Zdenková A, Hill M, Dusková M, et al. Efficacy and safety of ursodeoxycholic acid in patients with intrahepatic cholestasis of pregnancy. Ann Hepatol 2016; 15: 757-61. (Among 191 pregnant women with intrahepatic cholestasis of pregnancy treated with ursodiol, liver test abnormalities improved in 86% and therapy was well tolerated with minor side effects only, including diarrhea [5%] and skin rash [0.5%]; no mention of ALT elevations or worsening of liver disease). 27493115
Assis DN, Abdelghany O, Cai SY, Gossard AA, Eaton JE, Keach JC, Deng Y, et al. Combination therapy of all-trans retinoic acid with ursodeoxycholic acid in patients with primary sclerosing cholangitis: a human pilot study. J Clin Gastroenterol 2017; 51: e11-e16. (Among 19 patients treated with ursodiol to which was added all-trans retinoic acid, 4 withdrew early and in the remaining 15 there was a slight decrease in serum Alk P [277 to 243 U/L] and ALT levels [76 to 46 U/L], which rose to pretreatment levels upon stopping the retinoic acid). 27428727
Nevens F, Andreone P, Mazzella G, Strasser SI, Bowlus C, Invernizzi P, Drenth JP, et al.; POISE Study Group. A placebo-controlled trial of obeticholic acid in primary biliary cholangitis. N Engl J Med 2016; 375: 631-43. (Among 216 patients with PBC treated with OCA [5-10 mg daily] or placebo for 12 months, serum Alk P levels decreased by 35% and 41% with OCA but only by 4% with placebo, while symptoms of pruritus worsened and serious adverse event rates were more common with OCA [15% vs 4%]). 27532829

## OTHER REFERENCE LINKS

1. Recent References on Ursodiol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ursodiol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ursodiol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ursodiol)